# Leniolisib

## OVERVIEW

### Introduction

Leniolisib is an orally administered kinase inhibitor that is used to treat adults and children 12 years of age or older with Activated Phosphoinositide-3-kinase-delta Syndrome (APDS), an extremely rare, inherited immunodeficiency disease. Leniolisib has had very limited clinical use but has not been reported to cause elevations in liver enzymes and has not been linked to episodes of clinically apparent liver injury.

### Background

Leniolisib (len” i oh lis’ ib) is an orally available small molecule inhibitor of phosphoinositide-3-kinase delta (PI3Kδ) and is used to treat patients with APDS, an extremely rare, inherited form of immunodeficiency that is estimated to affect fewer than 1000 persons worldwide. It is inherited as an autosomal dominant condition and exists in two forms: APDS1 due to a gain-of-function mutation in p110δ in the catalytic site of PIK3 and ADPS2 due to a loss-of-function mutation in p85 in the regulatory subunit. Both mutations result in hyperactivity of the mTOR/AKT signaling pathway which causes dysregulation of B and T cell functions and subset numbers. The disease typically presents in infancy and childhood with frequent sinopulmonary bacterial infections accompanied by lymphadenopathy, hepatosplenomegaly and gastrointestinal involvement. Autoimmune phenomena often arise during middle childhood and lymphomas in adulthood. There has been no established, effective therapy for APDS besides treatment of the complications and off-label use of corticosteroids, mTOR inhibitors, and hematopoietic stem cell transplantation which has variable results. Leniolisib was the first drug developed for APDS, and in a small, 12-week randomized placebo controlled trial, it was found to improve naïve B cell numbers and function and lead to decrease in lymphadenopathy and splenomegaly. Further improvements in symptoms and signs were found with long term therapy. Leniolisib was approved as therapy for adults and children 12 years of age or older (and weight above 45 Kg) in 2023. Leniolisib is available in tablets of 70 mg under the brand name Joenja. The recommended dose is 70 mg twice daily. Therapy is generally well tolerated, but reported adverse events include sinusitis, atopic dermatitis, fatigue, diarrhea, fever, back and neck pain, and alopecia, many of which symptoms may be partially due to the underlying immune deficiency. Laboratory abnormalities include decrease in neutrophils, which are rarely to levels of concern. Severe adverse events are those due to the underlying disease and include severe bacterial infections and chronic viral infections.

### Hepatotoxicity

In the prelicensure clinical trials of leniolisib in patients with APDS, ALT elevations were rarely described, and there were no reports of hepatic adverse events or discontinuations because of abnormal liver tests. Intermittent elevations in liver enzymes are not uncommon in patients with untreated APDS due to bacterial, viral and opportunistic infections. Since its approval in the United States, there have been no reported cases of clinically apparent liver injury associated with leniolisib therapy, but the drug has had very limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from leniolisib is unknown. Leniolisib is metabolized by the cytochrome P450 system, predominantly by CYP 3A4 and is susceptible to drug-drug interactions with inducers or inhibitors of CYP 3A4 and may affect levels of drugs that are substrates of this drug metabolizing enzyme.

### Outcome and Management

The product label for leniolisib does not recommend routine monitoring of liver laboratory tests during therapy. Serum aminotransferase elevations above 5 times the upper limit of normal (if detected) should lead to a search for alternative causes of liver enzyme elevations and, if none are found, to dose reduction or temporary cessation of treatment with careful monitoring. Cross sensitivity to liver injury has not been described with the other medications used off label to treat APDS.

Drug Class: Genetic Disorder Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Leniolisib – Joenja®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Leniolisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Leniolisib | 1354690-24-6 | C21-H25-F3-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 21 July 2024

Abbreviations: APDS, Activated Phosphoinositide-3-kinase delta Syndrome; PI3Kδ, phosphoinisotide-3-kinase delta; PIP3, phosphatidyl-3,4,5-triphosphate; ULN, upper limit of normal.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/217759Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of leniolisib based upon results of a 12-week randomized controlled trial in 38 adults and 12 children with APDS followed by open label use of leniolisib for a median of 2 years, mentions that it was well tolerated with adverse events due largely due to the underlying condition with no evidence for hepatic injury, and “mean values for clinical chemistry patterns were similar across treatment arms”).
Hoegenauer K, Soldermann N, Zécri F, Strang RS, Graveleau N, Wolf RM, Cooke NG, et al. Discovery of CDZ173 (leniolisib), representing a structurally novel class of PI3K delta-selective inhibitors. ACS Med Chem Lett. 2017;8:975-980. (Description of the development of a specific inhibitor of the delta isoform of PI3K (leniolisib) which was a potent inhibitor of B and T cell function in vitro and inhibited antigen-specific antibody production and reduced disease symptoms in animal models of inflammatory arthritis). 28947947
Rao VK, Webster S, Šedivá A, Plebani A, Schuetz C, Shcherbina A, Conlon N, et al. A randomized, placebo-controlled phase 3 trial of the PI3Kδ inhibitor leniolisib for activated PI3Kδ syndrome. Blood. 2023;141:971-983. (Among 30 patients with APDS aged 12 years and older enrolled in a 12-week placebo controlled trial, those receiving leniolisib had a decrease in lymph node and spleen size and increase in percentage of naïve B cells, with a drug-related adverse event rate lower than with placebo [24% vs 30%]). 36399712
Duggan S, Al-Salama ZT. Leniolisib: first approval. Drugs. 2023;83:943-948. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of leniolisib shortly after its approval for APDS in the US, mentions that leniolisib was generally well tolerated with similar high adverse event rates in leniolisib and placebo treated groups [86% vs 90%] and with serious adverse events in 15% vs 20%; no mention of ALT elevations or hepatotoxicity). 37256490
Rao VK, Kulm E, Šedivá A, Plebani A, Schuetz C, Shcherbina A, Dalm VA, et al. Interim analysis: open-label extension study of leniolisib for patients with APDS. J Allergy Clin Immunol. 2024;153:265-274.e9. (Among 37 patients with APDS enrolled in an open label extension study of leniolisib with a follow up of up to 5 years [median 2 years], 32 [87%] reported at least one treatment emergent adverse event, two of which were elevations of ALT levels greater than 5 times ULN, both of which were without jaundice, resolved within two weeks, and were judged to be unrelated to therapy). 37797893
Doroudchi MA, Stephens AV, Wang Z, Dhami J, Butte MJ. APDS patients with immune-complex vasculitis and resolution with leniolisib. Clin Immunol. 2024;262:110176. (Among 3 patients with APDS and vasculitis poorly controlled by corticosteroids, treatment with leniolisib led to complete resolution and ability to stop corticosteroids; no mention of hepatic involvement). 38462154
Rao VK, Kulm E, Grossman J, Buchbinder D, Chong H, Bradt J, Webster S, et al. Long-term treatment with selective PI3Kδ inhibitor leniolisib in adults with activated PI3Kδ syndrome. Blood Adv. 2024;8:3092-3108. (In 6 adult patients with APDS treated with leniolisib for up to 6 years, quality of life, socialization, and physical capabilities improved and after the first year of exposure, infections and gastrointestinal complications attenuated while drug related adverse events were uncommon; in one participant with abnormal liver enzymes, ALT levels fell into the normal range and in a second with “hepatopathy”, the condition improved). 38593221

## OTHER REFERENCE LINKS

Recent References on Leniolisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Leniolisib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Leniolisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Leniolisib)